# Telbivudine

## OVERVIEW

### Introduction

Telbivudine is a nucleoside analogue and antiviral inhibitor of hepatitis B virus (HBV) replication which is used alone and in combination with other agents in the therapy of the hepatitis B. Telbivudine does not appear to be a significant cause of drug induced liver injury, but can be associated with flares of the underlying hepatitis B either during therapy or upon withdrawal.

### Background

Telbivudine (tel biv' ue deen) is the L-enantiomer of deoxythymidine (LdT) and has antiviral activity against HBV replication both in vitro and in vivo. Telbivudine is phosphorylated intracellularly to the triphosphate which inhibits the HBV polymerase and competes with deoxythymidine for incorporation into the growing viral DNA, causing inhibition of polymerase activity and DNA chain termination. Telbivudine has little or no activity against HIV replication. Telbivudine was approved in the United States in 2006 as therapy of chronic hepatitis B, either alone or in combination with other agents. It was withdrawn from the United States market in 2016 largely for economic reasons. Telbivudine was previously available as 600 mg tablets under the brand name Tyzeka. The recommended adult dose was 600 mg orally once daily. Side effects of telbivudine are uncommon. Studies of telbivudine therapy during pregnancy suggest that it is safe for pregnant women and can lower the rate of maternal-infant transmission of hepatitis B if administered in the last trimester. It was never approved for this indication in the United States.

### Hepatotoxicity

Telbivudine shares many features with the other L-nucleosides (lamivudine, emtricitabine) and has been linked to transient flares of hepatitis B during and after treatment of chronic hepatitis B. Serum ALT elevations above 3 times normal occurred in 5% to 10% of patients on telbivudine, which was comparable to other nucleoside analogues. Three types of flares can arise with nucleoside analogue therapy: transient and usually asymptomatic flares around the time of initiation of therapy (treatment flares), exacerbations of disease after development of antiviral resistance to telbivudine (breakthrough flares) and after stopping treatment (withdrawal flares). Cases of exacerbation of hepatitis B after development of antiviral resistance or upon telbivudine withdrawal can be severe and some cases have qualified as acute liver failure. No instances of lactic acidosis with hepatic steatosis have been reported with telbivudine therapy of hepatitis B, but isolated cases of suspected mitochondrial injury with myopathy have been reported. In trials of telbivudine therapy in pregnant women with HBsAg and HBeAg in serum and high levels of HBV DNA, therapy appeared to lessen if not eliminate maternal infant transmission, but withdrawal flares of hepatitis B occurred in some women with active disease and ALT elevations before therapy. In women with “immune tolerant” hepatitis B with high levels of HBV DNA without serum aminotransferase elevations, withdrawal flares are uncommon and levels of HBV DNA rise to previous levels on stopping therapy but without a concurrent flare of disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The apparent absence of significant hepatotoxicity from telbivudine may be due to its lack of hepatic metabolism. In vitro, telbivudine has little activity against mitochondrial polymerase gamma, inhibition of which has been implicated in the syndrome of hepatic mitochondrial injury with lactic acidosis, steatosis and hepatic failure.

### Outcome and Management

Flares of hepatitis B during and after telbivudine therapy can range in severity from mild, transient ALT elevations to severe acute liver injury resulting in hepatic failure and death. Flares occurring at initiation of therapy are usually mild and not associated with symptoms or jaundice. Flares associated with development of antiviral resistance and withdrawal flares can be severe. As a result, patients who develop evidence of antiviral resistance to telbivudine should be monitored carefully and switched to or have added another agent with a different pattern of resistance. Upon withdrawal of telbivudine, patients should be monitored carefully and promptly restarted on antiviral therapy if signs of severe injury arise.

Agents used in therapy of HBV infection include adefovir, emtricitabine, entecavir, lamivudine, telbivudine, tenofovir, interferon alfa and peginterferon.

Drug Class: Antiviral Agents, Antiretroviral Agents, Hepatitis B Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Didanosine, Emtricitabine, Entecavir, Lamivudine, Stavudine, Tenofovir, Zidovudine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Telbivudine – Tyzeka®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=telbivudine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Telbivudine | 3424-98-4 | C10-H14-N2-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2020

Núñez M. Hepatitis treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 511-2. (Review of hepatotoxicity of antiviral agents; mentions the potential of severe flares of disease upon withdrawal of therapy in chronic hepatitis B).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1593-622. (Textbook of pharmacology and therapeutics).
Lewis W, Dalakas MC. (1995). Mitochondrial toxicity of antiviral drugs. Nature Med. (Review of mechanisms for mitochondrial injury by nucleoside analogues including inhibition of mitochondrial DNA polymerase gamma).
Lai CL, Leung N, Teo EK, Tong M, Wong F, Hann HW, Han S, et al. (2005). Telbivudine Phase II Investigator Group. A 1-year trial of telbivudine, lamivudine, and the combination in patients with hepatitis B e antigen-positive chronic hepatitis B. Gastroenterology. (One year course of telbivudine vs lamivudine vs combination of both in 104 patients with hepatitis B; ALT elevations >3 times ULN occurred in only 1 of 44 [2%] telbivudine-treated patients).
Chan HL, Heathcote EJ, Marcellin P, Lai CL, Cho M, Moon YM, Chao YC, et al. (2007). 018 Study Group. Treatment of hepatitis B e antigen positive chronic hepatitis with telbivudine or adefovir: a randomized trial. Ann Intern Med. (Trial of telbivudine vs adefovir for 52 weeks in 131 patients with chronic hepatitis B; rates of ALT elevations and flares of hepatitis were not provided).
Bridges EG, Selden JR, Luo S. (2008). Nonclinical safety profile of telbivudine, a novel potent antiviral agent for treatment of hepatitis B. Antimicrob Agents Chemother. (Animal studies using high doses of telbivudine demonstrated no hepatotoxicity).
Lai CL, Gane E, Liaw YF, Hsu CW, Thongsawat S, Wang Y, Chen Y, et al., Globe Study Group. (2007). Telbivudine versus lamivudine in patients with chronic hepatitis B. N Engl J Med. (Trial of telbivudine [600 mg/day] vs lamivudine [100 mg/day] for 52 weeks in 1370 patients with chronic hepatitis B; ALT >3 times ULN occurred in 3.7% on telbivudine vs 6.3% on lamivudine; 1 patient on lamivudine developed antiviral resistance and liver failure requiring liver transplant).
Hou J, Yin YK, Xu D, Tan D, Niu J, Zhou X, Wang Y, et al. (2008). Telbivudine versus lamivudine in Chinese patients with chronic hepatitis B: Results at 1 year of a randomized, double-blind trial. Hepatology. (Trial of telbivudine vs lamivudine for 52 weeks in 332 patients with hepatitis B; ALT elevations >3 times normal occurred in 9.1% of lamivudine vs 5.4% of telbivudine treated subjects, usually associated with viral breakthrough; none fatal).
Fontana RJ. (2009). Side effects of long-term oral antiviral therapy for hepatitis B. Hepatology. (Review of side effects of nucleoside analogues used to treat chronic hepatitis B).
Liaw YF, Gane E, Leung N, Zeuzem S, Wang Y, Lai CL, Heathcote EJ, et al., GLOBE Study Group. (2009). 2-Year GLOBE trial results: telbivudine is superior to lamivudine in patients with chronic hepatitis B. Gastroenterology. (2 year results from Globe trial [Lai, 2007]: ALT levels >3 times ULN occurred in 6.3% of telbivudine vs 11.6% of lamivudine-treated subjects; 1 patient on telbivudine with antiviral resistance developed liver failure, but survived).
Finsterer J, Ay L. (2010). Myotoxicity of telbivudine in pre-existing muscle damage. Virol J. (27 year old man with chronic hepatitis B developed myalgias 3 weeks after starting telbivudine [CPK 3243 U/L], improving upon stopping).
Zou XJ, Jiang XQ, Tian DY. (2011). Clinical features and risk factors of creatine kinase elevations and myopathy associated with telbivudine. J Viral Hepat. (Among 200 patients with chronic hepatitis B treated with telbivudine for 3 years or more, 84% had at least one CPK elevation and 5% developed symptomatic myopathy [CPK more than 7 times ULN], but most abnormalities resolved spontaneously except in 3 patients in whom it resolved once they were switched to adefovir).
Han GR, Cao MK, Zhao W, Jiang HX, Wang CM, Bai SF, Yue X, et al. (2011). A prospective and open-label study for the efficacy and safety of telbivudine in pregnancy for the prevention of perinatal transmission of hepatitis B virus infection. J Hepatol. (Controlled trial of telbivudine vs no treatment during the latter part of pregnancy [starting between weeks 20 and 33] in 229 Chinese women with HBsAg, HBeAg and high levels of HBV DNA in serum; transmission of HBV to the newborn occurred in 0% of newborns of telbivudine-treated vs 8% of those of untreated mothers; after withdrawal of telbivudine after delivery in 38 mothers, none had a flare of hepatitis with ALT elevations >10 times ULN).
Dang S, Gao N, Zhang X, Jia X. (2011). Rhabdomyolysis in a 48-year-old man with hepatitis B-induced cirrhosis. Am J Med Sci. (48 year old man with chronic hepatitis B and cirrhosis developed abdominal pain and swelling and was found to have ascites and elevated CPK [3110 U/L]; despite stopping therapy, he developed progressive rhabdomyolysis and died of renal failure).
Gane EJ, Wang Y, Liaw YF, Hou J, Thongsawat S, Wan M, Moon YM, Jia J, Chao YC, Niu J, Leung N, Samuel D, Hsu CW, Bao W, Lopez P, Avila C. (2011). Efficacy and safety of prolonged 3-year telbivudine treatment in patients with chronic hepatitis B. Liver Int. (Further follow up of trial of telbivudine [Lai 2007] on safety in 399 patients treated for at least 3 years identified CPK elevations >7 times ULN in 55 [13%], myopathy in 22 [5%] and ALT flares >10 times ULN in 11 [3%]).
Chan HL, Chen YC, Gane EJ, Sarin SK, Suh DJ, Piratvisuth T, Prabhakar B, et al. (2012). Randomized clinical trial: efficacy and safety of telbivudine and lamivudine in treatment-naïve patients with HBV-related decompensated cirrhosis. J Viral Hepat. (In a controlled trial of telbivudine vs lamivudine in 228 patients with chronic hepatitis B and hepatic decompensation, the mortality rate from end stage liver disease at 2 years was 16%, but no deaths were considered drug related; one patient on telbivudine developed myopathy).
Wang J, Wang M, Huang Y. (2013). Acute liver failure resulting from discontinuation of nucleoside analogues in chronic hepatitis B patients: A report of two cases. Scand J Infect Dis. (Two patients, 37 and 39 year old men, discontinued antiviral therapy [lamivudine and adefovir] on their own and developed acute on chronic hepatic failure [bilirubin 44.5 and 26.6 mg/dL, ALT 387 and 87 U/L, INR 2.47 and 2.44, HBV DNA 20,000-200,000 copies/mL], one died and one underwent emergency liver transplant despite restarting therapy with telbivudine).
Chen EQ, Zhou TY, Bai L, Wang JR, Yan LB, Liang LB, Tang H. (2012). Lamivudine plus adefovir or telbivudine plus adefovir for chronic hepatitis B patients with suboptimal response to adefovir. Antivir Ther. (Among 72 patients with chronic hepatitis B who had a suboptimal response to adefovir, lamivudine was added in 37 and telbivudine in 35 patients; no worsening of liver disease was reported).
Ahn SH, Kweon YO, Paik SW, Sohn JH, Lee KS, Kim DJ, Piratvisuth T, et al. (2012). Telbivudine in combination with adefovir versus adefovir monotherapy in HBeAg-positive, lamivudine-resistant chronic hepatitis B. Hepatol Int. (Among 42 patients with chronic hepatitis B who had lamivudine resistance, 21 were treated with adefovir alone and 21 with adefovir and telbivudine; 1 patient in each group had an ALT flare during therapy [ALT 1743 and 1362 U/L], but both evidently resolved without discontinuation).
Kim EH, Park H, Lee KH, Ahn SH, Kim SM, Han KH. (2013). Two cases of telbivudine-induced myopathy in siblings with chronic hepatitis B. Clin Mol Hepatol. (28 and 25 year old brothers developed muscle weakness 5 and 12 months after starting telbivudine for hepatitis B [bilirubin 0.9 and 0.4 mg/dL, ALT 26 and 57 U/L, CPK 788 and 2992 U/L], improving upon switching to entecavir).
Wang Y, Thongsawat S, Gane EJ, Liaw YF, Jia J, Hou J, Chan HL, Papatheodoridis G, Wan M, Niu J, Bao W, Trylesinski A, Naoumov NV. (2013). Efficacy and safety of continuous 4-year telbivudine treatment in patients with chronic hepatitis B. J Viral Hepat. (Further follow up of controlled trials of telbivudine for chronic hepatitis B with safety data on 655 patients reported cumulative CK elevations in 104 [16%], myopathy in 4 [1%] and ALT flares in 42 [6%], 13 being early on treatment flares and 42 breakthrough flares).
Zhang H, Pan CQ, Pang Q, Tian R, Yan M, Liu X. (2014). Telbivudine or lamivudine use in late pregnancy safely reduces perinatal transmission of hepatitis B virus in real-life practice. Hepatology. (Among 648 HBeAg positive pregnant women with 52 weeks of follow up, treated with telbivudine, lamivudine or no therapy during the last trimester, 16% on telbivudine, 4% of lamivudine and 3% of untreated women had an on treatment flare of ALT, but all were asymptomatic and less than 5 times ULN; no mention of withdrawal flares).
Marcellin P, Wursthorn K, Wedemeyer H, Chuang WL, Lau G, Avila C, Peng CY, et al. (2015). Telbivudine plus pegylated interferon alfa-2a in a randomized study in chronic hepatitis B is associated with an unexpected high rate of peripheral neuropathy. J Hepatol. (Among 159 HBeAg positive adults with chronic hepatitis B treated with telbivudine, peginterferon or both, neuropathy arose in 14% of those on both agents vs 2% on telbivudine alone and none of the peginterferon alone group, which led to the early discontinuation of the trial).
Wu Q, Huang H, Sun X, Pan M, He Y, Tan S, Zeng Y, et al. (2015). Telbivudine prevents vertical transmission of hepatitis B virus from women with high viral loads: a prospective long-term study. Clin Gastroenterol Hepatol. (Among 279 HBeAg positive women with chronic hepatitis B and high levels of HBV DNA treated with telbivudine during the last trimester, rates of transmission were 0% compared to 15% of subjects who refused antiviral therapy; no serious adverse events occurred and there was no mention of on treatment or withdrawal ALT flares).
Han GR, Jiang HX, Yue X, Ding Y, Wang CM, Wang GJ, Yang YF. (2015). Efficacy and safety of telbivudine treatment: an open-label, prospective study in pregnant women for the prevention of perinatal transmission of hepatitis B virus infection. J Viral Hepat. (Among 454 HBeAg positive pregnant women with chronic hepatitis B and normal ALT levels despite high levels of HBV DNA treated with telbivudine or given no therapy starting in the 2nd or 3rd trimester, rates of transmission were none vs 9% [8/86] and 46 of 236 women [20%] who discontinued therapy one month postpartum had a withdrawal flare, although in only 3 [1.3%] did levels rise about 5 times ULN and no woman required therapy as all levels eventually fell into the normal range).
Tsai MC, Chen CH, Tseng PL, Hung CH, Chiu KW, Wang JH, Lu SN, et al. (2016). Comparison of renal safety and efficacy of telbivudine, entecavir and tenofovir treatment in chronic hepatitis B patients: real world experience. Clin Microbiol Infect. (Among 587 Chinese patients positive chronic hepatitis B [~50% with cirrhosis] treated with tenofovir, entecavir or telbivudine for at least one year, viral resistance developed in none on tenofovir, 3.4% on entecavir and 23% of telbivudine, while renal function was stable except in those on tenofovir in whom a decrease occurred by year 5 and rates of hepatocellular carcinoma were highest among those with cirrhosis treated with telbivudine).
Hu Y, Xu C, Xu B, Hu L, Liu Q, Chen J, Liu J, et al. (2018). Safety and efficacy of telbivudine in late pregnancy to prevent mother-to-child transmission of hepatitis B virus: A multicenter prospective cohort study. J Viral Hepat. (Among 328 HBeAg positive pregnant Chinese women who were treated with telbivudine during the last trimester or elected not to receive therapy, there were similar rates of ALT elevations in the postpartum period [21% vs 20%], whereas none of the 128 infants born to treated mothers developed HBV infection compared to 2 of 156 [1.5%] infants of controls ).

## OTHER REFERENCE LINKS

1 Recent References on Telbivudine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Telbivudine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Telbivudine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Telbivudine)